# Vutrisiran

## OVERVIEW

### Introduction

Vutrisiran is a synthetic small interfering RNA (siRNA) molecule directed against the mRNA of transthyretin that is used to treat adults with the polyneuropathy of hereditary transthyretin-mediated amyloidosis. Vutrisiran has not been linked to serum aminotransferase elevations during therapy or to instances of clinically apparent liver injury with symptoms or jaundice.

### Background

Vutrisiran (vue” tri sir’ an) is a synthetic, double-stranded, small interfering RNA (siRNA) directed against the mRNA of transthyretin, a serum protein made in the liver whose major function is transport of vitamin A and thyroxine. Rare mutations in the transthyretin gene result in accumulation of large amyloid deposits of misfolded transthyretin molecules most prominently in peripheral nerves and the heart. Patients with inherited transthyretin amyloidosis typically present with polyneuropathy or autonomic dysfunction followed by cardiomyopathy which, if untreated, is usually fatal within 5 to 12 years. Vutrisiran was developed to reduce production of transthyretin (both the wild type and mutant forms) and prevent further amyloid deposits. Vutrisiran is administered subcutaneously, and uptake by the liver is facilitated by three covalently linked N-acetylgalactosamine residues which bind to the liver specific cell surface, asialoglycoprotein receptor. Once taken up by hepatocytes, the siRNA is cleaved into smaller fragments and separated into single strands that bind and silence the mRNA of transthyretin. In animal models, vutrisiran reduced transthyretin mRNA levels in liver and lowered serum levels of transthyretin by more than 50%. In trials of vutrisiran in patients with hereditary transthyretin amyloidosis with polyneuropathy, subcutaneous injections given every three months resulted in rapid and sustained reductions in serum transthyretin levels (averaging ~80%) and significant improvements in neuropathy and quality of life scales compared to historical placebo groups. Vutrisiran was approved for use in the United States in 2022 for adults with transthyretin amyloidosis and polyneuropathy. It is under evaluation for efficacy and safety in patients with cardiomyopathy due to transthyretin amyloidosis. Vutrisiran is available in solution in single dose prefilled syringes of 25 mg in 0.5 mL under the brand name Amvuttra. The recommended dose regimen is 25 mg administered subcutaneously every 3 months. Administration by a health care provider is recommended. Vutrisiran is generally well tolerated but side effects can include injection site reactions, fatigue, arthralgias, diarrhea and musculoskeletal pains. In preregistration studies, 3% of vutrisiran treated patients developed anti-drug antibodies, but their presence was not associated with decreased efficacy or safety. Because vutrisiran reduces serum transthyretin levels, it also reduces serum vitamin A levels and vitamin A supplementation is recommended, but only in doses within the recommended daily allowance.

### Hepatotoxicity

In preregistration trials, vutrisiran therapy was well tolerated and serum aminotransferase levels were uncommon and no more frequent that with placebo treatment. The elevations arose in less than 1% of patients that were invariably transient, mild-to-moderate in severity, and without accompanying symptoms or jaundice. Since its approval, there have been no published reports of liver injury attributed to vutrisiran therapy. Thus, vutrisiran is an unlikely cause of clinically apparent liver injury, although it still has had limited widescale clinical use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The possible cause of hepatic injury from vutrisiran or other siRNA therapeutics is not known. One possibility is that suppression of transthyretin levels might cause or predispose to liver injury. Vutrisiran, like other siRNA therapeutic agents, is metabolized intracellularly by nucleases and is not a substrate of cytochrome P450 enzymes or hepatic transporters.

### Outcome and Management

Vutrisiran has not been linked to liver test abnormalities or to clinically apparent liver injury and regular monitoring of routine liver tests is not recommended.

Drug Class: Genetic Disorder Agents, siRNA and Antisense Agents

Other Therapeutic siRNA-based Agents: Givosiran, Inclisiran, Lumasiran, Patisiran

Other Drugs for Transthyretin-Mediated Amyloidosis: Acoramidis, Eplontersen, Inotersen, Patisiran, Tafamidis

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Vutrisiran – Amvuttra®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=8db0facb-81b6-4006-9239-27dc6409c5d3)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Vutrisiran | 1867157-35-4 (https://pubchem.ncbi.nlm.nih.gov/substance/381128126) | C530-H672-F9-N171-Na43-O323-P43-S6 | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 25 February 2025

Abbreviations: mRNA, messenger RNA; siRNA, small interfering RNA.

FDA. Vutrisiran. Clinical Review. 2022. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2022/215515Orig1s000MedR.pdf (The FDA website with analysis of data submitted in support of approval of vutrisiran, includes product labels and clinical review for its efficacy and safety reported that there were no serious hepatic adverse events or ALT elevations above 3 times ULN among the 122 patients who received vutrisiran in preregistration trials).
Setten RL, Rossi JJ, Han SP. The current state and future directions of RNAi-based therapeutics. Nat Rev Drug Discov 2019; 18: 421-46. (Extensive review of gene silencing using RNA interference pathways and the potential of RNAi therapeutics which have promise in many genetic and acquired diseases including transthyretin amyloidosis [transthyretin], HIV infection [CCR5], HBV [HBV mRNA], alpha-1-antitrypsin deficiency [zz A1AT], hypercholesterolemia [PCSK9]). 30846871
Yadav JD, Othee H, Chan KA, Man DC, Belliveau PP, Towle J. Transthyretin amyloid cardiomyopathy-current and future therapies. Ann Pharmacother. 2021;55:1502-1514. (Review of the clinical syndrome of transthyretin amyloid cardiomyopathy and newer agents being evaluated for its treatment including patisiran and vutrisiran, which are under evaluation for evidence of clinical benefit for the cardiomyopathy of transthyretin amyloidosis; no mention of ALT elevations or hepatotoxicity). 33685242
Adams D, Tournev IL, Taylor MS, Coelho T, Planté-Bordeneuve V, Berk JL, González-Duarte A, et al.; HELIOS-A Collaborators. Efficacy and safety of vutrisiran for patients with hereditary transthyretin-mediated amyloidosis with polyneuropathy: a randomized clinical trial. Amyloid. 2023;30:1-9. (Among 164 patients with hereditary transthyretin-mediated amyloidosis with polyneuropathy treated with vutrisiran [25 mg every 3 months] or patisiran [0.3 mg/kg every 3 weeks] subcutaneously for up to 18 months, neuropathy and quality of life scales improved with both agents as compared to external, historical placebo treated controls [n=77] and adverse events were generally mild and similar to those in placebo and “there were no safety signals regarding liver function tests”). 35875890
Keam SJ. Vutrisiran: first approval. Drugs. 2022;82:1419-1425. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of vutrisiran shortly after its approval in the US, mentions that it is generally well tolerated and there were no safety signals related to vutrisiran in relation to liver function tests”). 35997942
Ranasinghe P, Addison ML, Dear JW, Webb DJ. Small interfering RNA: Discovery, pharmacology and clinical development–An introductory review. Br J Pharmacol. 2023;180:2697-2720. (Review of the history of development, mechanism of action, methods of delivery, clinical efficacy and safety of RNA silencing drugs including lumasiran, givosiran, inclisiran, patisiran and vutrisiran, discusses adverse events from vutrisiran of injection site reactions, but does not mention hepatotoxicity or ALT elevations). 36250252
Aimo A, Castiglione V, Rapezzi C, Franzini M, Panichella G, Vergaro G, Gillmore J, et al. RNA-targeting and gene editing therapies for transthyretin amyloidosis. Nat Rev Cardiol. 2022;19:655-667. (Review of the molecular approaches to therapy of transthyretin-related amyloidosis including small interfering RNA [siRNA, patisiran, vutrisiran], antisense RNA [inotersen, eplontersen], CRISPR-Cas9 therapy, and molecular stabilization agents [acoramidis, tafamidis], some of which been linked to minor serum aminotransferase elevations during therapy [vutrisiran, eplontersen], but not to clinically apparent liver injury). 35322226
Liu Y, Li H, Hu C, Tan L, Yin P, Li Z, Zhou S, Su L. A real-world pharmacovigilance analysis for transthyretin inhibitors: findings from the FDA adverse event reporting database. Front Pharmacol. 2024;15:1368244. (Analysis of the FDA Adverse Event Reporting System [FAES] reports on transthyretin inhibitors made over a 5-year period, found the top 50 events for vutrisiran the most frequent were falls, pains in extremities, malaise and asthenia, and there were 5 reports of hepatic enzyme increased, but no details provided). 38873427
Ruberg FL, Maurer MS. Cardiac amyloidosis due to transthyretin protein: a review. JAMA. 2024;331:778-791. (Review of the pathogenesis, genetics, clinical features, diagnosis, and treatment of transthyretin-mediated amyloidosis cardiomyopathy; no mention of ALT elevations or hepatotoxicity). 38441582

## OTHER REFERENCE LINKS

1. Recent References on Vutrisiran: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Vutrisiran/AE)%20AND%20Human%5bMH%5d%20AND%20(drug%20induced%20liver%20injury%20OR%20jaundice/CI%20OR%20bile%20duct%20diseases/CI%20OR%20liver/DE%20OR%20liver%20diseases/CI)%20AND%20(%221900%5C%5C1%5C%5C1%22%5bEDat%5d:%222999%5C%5C12%5C%5C31%22%5bEDat%5d))

2. Trials on Vutrisiran: from ClinicalTrials.gov (https://www.clinicaltrials.gov/ct2/results?term=Vutrisiran)